# Rosuvastatin

## OVERVIEW

### Introduction

Rosuvastatin is a commonly used cholesterol lowering agent (statin) that is associated with mild, asymptomatic and self-limited serum aminotransferase elevations during therapy, and rarely with clinically apparent acute liver injury.

### Background

Rosuvastatin (roe soo" va stat' in) is a potent, orally available inhibitor of hepatic 3-hydroxy-3-methylglutaryl-coenzyme A (HMG-CoA) reductase, the major rate-limiting enzyme in cholesterol synthesis. Like other members of its class (the “statins”), rosuvastatin lowers total serum cholesterol and low density lipoprotein (LDL) concentrations, thereby reducing the risk of atherosclerosis and its complications – myocardial infarction and stroke. Rosuvastatin was approved for use in the United States in 2003 and currently more than 40 million prescriptions are filled yearly. Rosuvastatin is indicated for the treatment of hypercholesterolemia in persons at high risk for coronary, cerebrovascular and peripheral artery disease and for children and adults with homozygous familial hypercholesterolemia. Rosuvastatin has been shown to slow progression of atherosclerosis and to prevent cardiovascular disease and is approved for those indications. Rosuvastatin is available in tablets of 5, 10, 20, and 40 mg generically and under the trade name Crestor. Rosuvastatin is one of the more potent statins available and is typically used in a comparably lower dose. The recommended dose in adults is 5 to 40 mg once daily, based upon tolerability and lipid levels. Persons of Asian descent should receive a lower dose (5 to 10 mg daily) because of alternations in its metabolism. More recent recommendations are that rosuvastatin be started at a maximum dose of 20 mg daily (10 mg in Asians, children, patients with renal impairment, and those on CYP 3A4 inhibitors). Common side effects are a major reason for dose adjustment and include muscle cramps, headache, joint aches, abdominal pain, nausea, and weakness, symptoms that occur with all currently available statins. Rare but potentially severe adverse events include liver injury, myopathy, rhabdomyolysis, and immune-mediated necrotizing myopathy.

### Hepatotoxicity

Rosuvastatin therapy is associated with mild, asymptomatic and usually transient serum aminotransferase elevations in 1% to 3% of patients. ALT levels above 3 times the upper limit of normal (ULN) occur slightly more frequently among rosuvastatin treated [1.1%] than placebo [0.5%] recipients. Serum enzyme elevations are more common with higher doses of rosuvastatin, being 2.2% with 40 mg daily. Most of these elevations are self-limited and do not require dose modification. Rosuvastatin is also associated with frank, clinically apparent hepatic injury but this is rare, estimated to occur in only 1:16,000 patients, a rate that is lower than atorvastatin (1:10,000) but higher than simvastatin (1:52,000). The onset is typically after 2 to 4 months and the pattern of serum enzyme elevations is usually hepatocellular, although cholestatic cases have also been reported. Rash, fever and eosinophilia are uncommon. Several statins including rosuvastatin have been linked to hepatitis with autoimmune features marked by ANA positivity, elevations in serum immunoglobulin levels, and a clinical response to corticosteroids. Such features are not, however, invariable (Case 1). The injury is usually self-limited and resolves rapidly once rosuvastatin is stopped, but it can be severe and fatal instances have been reported.

A challenge in the diagnosis of drug induced liver injury in patients on statins and particularly those on rosuvastatin is the rare occurrence of severe myopathy and rhabdomyolysis, which is often accompanied by serum ALT and AST elevations. These patients, however, present with muscle pain and weakness rather than fatigue, dark urine and jaundice. While ALT levels may be elevated, they are generally mild-to-moderate in severity and greatly overshadowed by marked elevations in AST and CPK which are typical of muscle injury. A further clue for the diagnosis is lack of elevations in Alk P and bilirubin and other specific markers of liver injury.

Likelihood score: A (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from rosuvastatin is unknown. Rosuvastatin is minimally (~10%) metabolized in the liver via CYP 2C9. The mild, self-limited ALT elevations may be due to a toxic intermediate of drug metabolism and the reversal of these elevations due to adaptation. The idiosyncratic, clinically apparent liver injury associated with rosuvastatin is often accompanied by autoimmune features and may, therefore, be caused by immune mechanisms.

### Outcome and Management

The product label for rosuvastatin recommends screening for liver test abnormalities before starting therapy and repeating tests as clinically indicated. The mild ALT elevations associated with rosuvastatin therapy are usually self-limited and do not require dose modification. Rosuvastatin should be stopped if ALT levels rise above 10-fold the ULN or persist in being above 5-fold elevated or are associated with symptoms. In the clinically apparent liver injury attributed to rosuvastatin, recovery is usually complete within 1 to 2 months. Recurrence of injury with rechallenge has been reported and should be avoided. Cases of chronic hepatitis, but no instances of vanishing bile duct syndrome attributable to rosuvastatin have been reported. In cases of autoimmune hepatitis-like injury, corticosteroids have been used when recovery does not occur promptly. If corticosteroids are used, the dose and duration of treatment should be kept to a minimum, and careful follow up after stopping is essential. Switching therapy to another statin after rosuvastatin induced injury is apparently safe, but few instances have been reported, and it should be done with careful monitoring for recurrence.

Drug Class: Antilipemic Agents

Other Drugs in the Subclass, Statins: Atorvastatin, Ezetimibe [used in combination], Fluvastatin, Lovastatin, Pitavastatin, Pravastatin, Simvastatin

## CASE REPORT

### Case 1. Acute self-limited hepatitis during rosuvastatin therapy.(1)

A 64 year old man developed jaundice approximately 15 weeks after starting rosuvastatin (10 mg daily) for hypercholesterolemia. He had a history of acute myocardial infarction four months previously, which was treated with angioplasty and stenting. Discharge medications included clopidogrel, aspirin, metoprolol, ramipril and atorvastatin. One week later he developed skin rash and minor ALT elevations (55 U/L), and rosuvastatin was substituted for atorvastatin. Subsequently, he felt well until 3 months later when he developed malaise, anorexia and upper abdominal discomfort followed by jaundice. On examination, he had no fever, rash or signs of chronic liver disease. Laboratory results showed elevations in serum bilirubin and aminotransferase levels, but normal alkaline phosphatase and GGT values (Table). Tests for hepatitis A, B, C, and E were negative as were routine autoantibodies. Ultrasonography of the liver and biliary tree was normal. Rosuvastatin was stopped while blood pressure and antiplatelet medications were continued. Liver test abnormalities improved promptly and were normal two weeks later.

#### Key Points

Medication: | Rosuvastatin (10 mg daily)
Pattern: | Hepatocellular (aminotransferase elevations only)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 15 weeks
Recovery: | 2 weeks
Other medications: | Clopidogrel, aspirin, metoprolol, ramipril, atorvastatin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin (mg/dL) | Other
Pre | | 20 | Normal | Normal | Discharge after heart attack
Pre | | 55 | | | Atorvastatin stopped
Atorvastatin stopped and rosuvastatin started
2 days | | 40
3 days | | 35
15 weeks | 0 | 775 | Normal | 2.6 | Admission: rosuvastatin stopped
15 weeks | 3 days | 198 | | 1.8 | INR Normal
16 weeks | 1 week | 40 | | Normal
17 weeks | 2 weeks | 30 | Normal | Normal
Normal Values | | <36 | <117 | <1.2

* Some values estimated from Figure 1.

#### Comment

The onset of hepatocellular injury approximately 3 months after starting rosuvastatin and the rapid recovery with stopping therapy makes the diagnosis of rosuvastatin induced acute hepatitis highly likely. Other diagnoses were appropriately ruled out, and there was documentation of normal liver tests before starting statin therapy. Acute, clinically apparent liver injury is rare with rosuvastatin therapy (~1:16,000 patients treated) and is rapidly reversible with prompt discontinuation of therapy. Rechallenge with rosuvastatin is inadvisable, but other statins might be initiated with careful monitoring of serum enzymes.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rosuvastatin – Generic, Crestor®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=rosuvastatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Rosuvastatin | 287714-41-4 | C22-H28-F-N3-O6-S

## CITED REFERENCE

1 Famularo G, Miele L, Minisola G, Grieco A. Liver toxicity of rosuvastatin therapy. World J Gastroenterol 2007; 13: 1286-8.17451217

## ANNOTATED BIBLIOGRAPHY

References updated: 21 March 2025

Abbreviations used: ANA, antinuclear antibody; HDL, high density lipoprotein; LDL, low density lipoprotein; OD, odds ratio.

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999; the statins have dose related hepatic effects in guinea pigs and rabbits, and transient elevations in aminotransferases occur in 1-5% of humans treated; several cases of clinically apparent liver injury from lovastatin and simvastatin have been published).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. Lipid lowering agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of lipid lowering agents; asymptomatic elevations in aminotransferases are common in patients receiving statins, but clinically significant hepatotoxicity is rare).
Gurgle H, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-618. (Textbook of pharmacology and therapeutics; “Serious hepatotoxicity is rare and unpredictable, with a rate of about 1 case per million person-years of use.” Multiple academic societies and the FDA recommend testing all patients for routine liver tests before starting statins but monitoring or retesting only if symptoms arise).
Brewer HB Jr. Benefit-risk assessment of rosuvastatin 10 to 40 milligrams. Am J Cardiol 2003; 92 (Suppl): 23K-29K. (Review of efficacy and safety of rosuvastatin in doses of up to 80 mg daily in 12,569 patients [14,231 patient years]: ALT elevations >3 times ULN occurred in 0.2% and similar rate in comparators: atorvastatin, simvastatin, and pravastatin). 12948873
Simonson SG, Martin PD, Mitchell P, Schneck DW, Lasseter KC, Warwick MJ. Pharmacokinetics and pharmacodynamics of rosuvastatin in subjects with hepatic impairment. Eur J Clin Pharmacol. 2003;58:669-75. (Pharmacokinetic studies of rosuvastatin [10 mg daily for 10 days] in 18 subjects, found normal peak and total area under the curve levels in 6 of 6 with Child Class A and 4 of 6 with Child Class B cirrhosis [alcoholic] compared to 6 of 6 subjects with normal liver function). 12610743
Shepherd J, Hunninghake DB, Stein EA, Kastelein JJ, Harris S, Pears J, Hutchinson HG. Safety of rosuvastatin. Am J Cardiol 2004; 94: 882-8. (Overview of safety of rosuvastatin based upon data from 12,400 patients in clinical trials using 5-40 mg daily; rates of adverse events similar to those with placebo, rates of ALT elevations >3 times ULN were 0.5% with 5, 0.1% with 10, 0.1% with 20, and 0.3% with 40 mg, with overall rates 0.2% similar to comparator statins). 15464670
Wolters LMM, Van Buuren HR. Rosuvastatin-associated hepatitis with autoimmune features (letter). Eur J Gastroenterol Hepatol 2005; 17: 589-90. (46 year old developed jaundice 9 weeks after starting rosuvastatin [bilirubin 7.9 mg/dL, ALT 2539 U/L, Alk P 151 U/L, IgG 2.4 g/dL, SMA1:160], improved upon stopping rosuvastatin, but eventually required long term corticosteroid therapy [during follow up for more than 4 years after this publication]). 15827453
Alsheikh-Ali AA, Ambrose MS, Kuvin JT, Karas RH. The safety of rosuvastatin as used in common clinical practice: a postmarketing analysis. Circulation 2005; 111: 3051-7. (Review of MedWatch adverse event reports on rosuvastatin over the first year of marketing; rates of liver related reports were 25 per million prescriptions for rosuvastatin compared to 4-5 for simvastatin, pravastatin and atorvastatin and rates also higher for comparable marketing period of the other statins). 15911706
McKenney JM. An assessment of statin safety. Am J Manag Care 2006; 12: S310-7. (Review of the safety of the statins; liver failure reported at a rate of 1 per million, which is similar to nonstatin-taking population, recommends monitoring based upon symptoms rather than blood test abnormalities). 17042673
Conforti A, Magro L, Moretti U, Scotto S, Motola D, Salvo F, Ros B, et al. Fluvastatin and hepatic reactions: a signal from spontaneous reporting in Italy. Drug Safety 2006; 29: 1163-72. (Italian Pharmacovigilance Group review of 35,757 adverse reaction reports; 1260 due to statins of which 178 were hepatic: 69 [36%] fluvastatin, 37 [21%] atorvastatin, 50 [28%] simvastatin, 16 [9%] pravastatin, 6 [3%] rosuvastatin; proportion reporting rate based on number of prescriptions was highest for fluvastatin [~9] compared to other agents [~2-3]). 17147462
Zipes DP, Zvaifler NJ, Glassock RJ, Gilman S, Muñoz A, Gogolak V, Gordis L, et al. Rosuvastatin: an independent analysis of risks and benefits. MedGenMed 2006; 8: 73. (Expert review of the literature concludes that safety and tolerability of rosuvastatin is similar to other statins, and rates of liver injury are very low). 16926812
McAfee AT, Ming EE, Seeger JD, Quinn SG, Ng EW, Danielson JD, Cutone JA, et al. The comparative safety of rosuvastatin: a retrospective matched cohort study in over 48,000 initiators of statin therapy. Pharmacoepidemiol Drug Saf 2006; 15: 444-53. (Analysis of electronic records on 11,249 patients starting rosuvastatin compared to 37,282 starting another statin; over the first 6 months of treatment, hepatic dysfunction reported in 2 [0.020%] starting rosuvastatin vs 8 [0.024%] starting other statins). 16761308
Goettsch WG, Heintjes EM, Kastelein JJ, Rabelink TJ, Johansson S, Herings RM. Results from a rosuvastatin historical cohort study in more than 45,000 Dutch statin users, a PHARMO study. Pharmacoepidemiol Drug Saf 2006; 15: 435-43. (Analysis of electronic database on more than 2 million Dutch residents comparing those on rosuvastatin [10,147], other statins [37,396] and non-users [99,935]; hepatic impairment identified in none on rosuvastatin, 4 [0.011%] on statins and 7 [0.006%] controls). 16761304
Silva MA, Swanson AC, Gandhi PJ, Tataronis GR. Statin-related adverse events: a meta-analysis. Clin Ther 2006; 28: 26-35. (Metaanalysis of adverse event rates in 18 placebo controlled trials of six statins in 71,108 patients; ALT elevations >3 times ULN in 1.7% of statin vs 1.4% placebo recipients; event rates highest with atorvastatin, lowest with fluvastatin). 16490577
Antonopoulos S, Mikros S, Mylonopoulou M, Kokkoris S, Giannoulis G. Rosuvastatin as a novel treatment of non-alcoholic fatty liver disease in hyperlipidemic patients. Atherosclerosis 2006; 184: 233-4. (Open label study of rosuvastatin [10 mg/day] for 8 months in 23 patients with nonalcoholic fatty liver disease; ALT levels fell to normal in all patients and no instance of hepatotoxicity). 16168995
Clearfield MB, Amerena J, Bassand JP, Hernández García HR, Miller SS, Sosef FF, Palmer MK, et al. Comparison of the efficacy and safety of rosuvastatin 10 mg and atorvastatin 20 mg in high-risk patients with hypercholesterolemia – Prospective study to evaluate the Use of Low doses of the Statins Atorvastatin and Rosuvastatin (PULSAR). Trials 2006; 7: 35. (Controlled trial comparing rosuvastatin [10 mg] vs atorvastatin [20 mg] daily for 6 weeks; one patient on atorvastatin had confirmed ALT elevations >3 times ULN; no clinically apparent liver injury). 17184550
Law M, Rudnicka AR. Statin safety: a systematic review. Am J Cardiol 2006; 97 (8A): 52C-60C. (Review of safety of statins; 38 cases of acute liver failure attributed to statins were submitted to MedWatch by end of 1999, which gives an estimated rate of 1 per million person years of use; rate of confirmed ALT elevations >3 times ULN is 0.1% with statins and 0.04% with placebo). 16581329
Guthrie RM, Martin DR. The safety of rosuvastatin: effects on renal and hepatic function. Expert Opin Drug Saf 2007; 6: 573-81. (Review of hepatic adverse events due to rosuvastatin without new information; ALT elevations occur at a similar rate during rosuvastatin as with other statins and average ~0.4%; acute liver failure has not been definitely linked to statins, estimated rate being ~1 per million patient years, similar to background rate; authors argue against routine monitoring of liver enzymes during rosuvastatin therapy). 17877444
Kasliwal R, Wilton LV, Cornelius V, Aurich-Barrera B, Shakir SA. Safety profile of rosuvastatin: results of a prescription-event monitoring study of 11,680 patients. Drug Saf 2007; 30: 157-70. (Postmarketing study of 11,680 patients on rosuvastatin; therapy stopped in 17.5% because of adverse events, myalgias being most frequent reason; ALT or AST elevations in 101 patients [~1%], but only 9 [~0.1%] had confirmed ALT values >3 times ULN, one patient developed an autoimmune hepatitis-like syndrome 4 months after starting rosuvastatin, resolving spontaneously with stopping, another patient had cholestatic jaundice). 17253880
Bhardwaj SS, Chalasani N. Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis 2007; 11: 597-613. (Review of hepatotoxicity of statins; reported rates of ALT or AST elevations >3 times ULN: atorvastatin 0.7%, fluvastatin 1.2%, lovastatin 0.6%, pravastatin 1.4%, rosuvastatin 0%, and simvastatin 1.8%. Usually asymptomatic, individual case reports of autoimmune hepatitis). 17723922
Stein EA, Amerena J, Ballantyne CM, Brice E, Farnier M, Guthrie RM, Harats D, et al. Long-term efficacy and safety of rosuvastatin 40 mg in patients with severe hypercholesterolemia. Am J Cardiol 2007; 100: 1387-96. (Open label, extension study of rosuvastatin [40 mg daily] for 2 years in 1,380 patients with severe hypercholesterolemia; confirmed ALT elevations >3 times ULN occurred in 0.8%, half resolved despite continuing therapy, no clinically apparent hepatitis or jaundice and no deaths from liver disease). 17950795
Merz T, Fuller SH. Elevated serum transaminase levels resulting from concomitant use of rosuvastatin and amiodarone. Am J Health Syst Pharm 2007; 64: 1818-21. (73 year old developed minimal ALT elevations on rosuvastatin which worsened two weeks after starting amiodarone [ALT 13→91→336 U/L], improving with stopping rosuvastatin despite continuing amiodarone, possibly demonstrating interaction between the two agents). 17724362
Famularo G, Miele L, Minisola G, Grieco A. Liver toxicity of rosuvastatin therapy. World J Gastroenterol 2007; 13: 1286-8. (64 year old man developed jaundice ~3 months after starting rosuvastatin [bilirubin 2.6 mg/dL, ALT 775 U/L, normal GGT, ANA negative], resolving within 2 weeks of stopping: case 1). 17451217
Crouse JR 3rd, Raichlen JS, Riley WA, Evans GW, Palmer MK, O'Leary DH, Grobbee DE, et al.; METEOR Study Group. Effect of rosuvastatin on progression of carotid intima-media thickness in low-risk individuals with subclinical atherosclerosis: the METEOR Trial. JAMA. 2007;297:1344-53. (Among 984 patients with hypercholesterolemia but no history of cardiovascular disease treated with rosuvastatin [40 mg] or placebo daily for a period of 2 years, LDL-cholesterol levels decreased by 49% in statin treated patients who had less progression of carotid intima-media thickening, while adverse event rates were similar to placebo treatment including myalgia [12.7% vs 12.1%] and ALT elevations above 3 times ULN [0.6% vs 0.4%], and there were no cases of clinically apparent hepatitis or rhabdomyolysis). 17384434
Ridker PM, Danielson E, Fonseca FA, Genest J, Gotto AM Jr, Kastelein JJ, Koenig W, et al.; JUPITER Study Group. Rosuvastatin to prevent vascular events in men and women with elevated C-reactive protein. N Engl J Med. 2008;359:2195-207. (Among 17,802 healthy adults with low risk for cardiovascular events [LDL-C less than 130 mg/dL] but elevated C-reactive protein treated with rosuvastatin [20 mg] or placebo once daily for a median of 1.9 years, LDL-cholesterol levels decreased by 50% and major cardiovascular event rates were lower with statin therapy, while adverse event rates were similar, such as serious events [15.2% vs 15.5%], muscle symptoms [16% vs 15.4%], myopathy [0.1% vs 0.1%], and ALT elevations above 3 times ULN [0.3% vs 0.2%], although new onset diabetes was more frequent with rosuvastatin [3.0% vs 2.4%]). 18997196
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug-Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 cases were attributed to atorvastatin, 3 to simvastatin/ezetimibe, and one each to pravastatin, fluvastatin, and simvastatin, but most cases were mild or not clearly attributable to the statin therapy; none related to rosuvastatin). 18955056
Oteri A, Catania MA, Russo A, Salvo F, Giacci L, Caputi AP, Polimeni G. Reversible acute hepatitis induced by rosuvastatin. South Med J 2008; 101: 768. (62 year old man developed jaundice 2 months after switching from simvastatin to rosuvastatin [10 mg daily] [bilirubin 6.1 mg/dL, ALT 2317 U/L, Alk P levels and ANA not reported], resolving within 3 weeks of stopping drug). 19209117
García-Rodríguez LA, Massó-González EL, Wallander MA, Johansson S. The safety of rosuvastatin in comparison with other statins in over 100,000 statin users in UK primary care. Pharmacoepidemiol Drug Saf 2008; 17: 943-52. (Analysis of electronic records on 10,289 patients starting rosuvastatin and 117,102 starting other statins [mostly simvastatin and atorvastatin] for adverse events; 4 cases [0.003%] of myopathy, 4 [0.003%] of rhabdomyolysis, and 6 [0.05%] of acute liver injury identified, but none in rosuvastatin users). 18425988
García-Rodríguez LA, González-Pérez A, Stang MR, Wallander MA, Johansson S. The safety of rosuvastatin in comparison with other statins in over 25,000 statin users in the Saskatchewan Health Databases. Pharmacoepidemiol Drug Saf 2008; 17: 953-61. (Analysis of electronic medical records on 25,238 first time statin users, 10,384 starting rosuvastatin; 2 cases each of myopathy, rhabdomyolysis and acute liver injury [all 0.008%], but both liver related adverse events occurred in atorvastatin treated patients). 18425987
Rubba P, Marotta G, Gentile M. Efficacy and safety of rosuvastatin in the management of dyslipidemia. Vasc Health Risk Manag 2009; 5: 343-52. (Review of mechanism of action, pharmacology, safety and efficacy of rosuvastatin; elevations of ALT levels >3 times ULN during rosuvastatin therapy are uncommon [<0.2%]). 19436657
Hippisley-Cox J, Coupland C. Unintended effects of statins in men and women in England and Wales: population based cohort study using the QResearch database. BMJ 2010; 340: c2197. (Among 225,922 new users of statins in a UK health care database, there was an increased risk of moderate or severe liver dysfunction [ALT >3 times ULN], usually within first 6 months and associated with higher doses of statins; relative risks were highest with fluvastatin [2.53 in women, 1.97 in men] and lowest with pravastatin [0.93 to 1.58], and intermediate for rosuvastatin [1.31 to 1.46]). 20488911
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 due to atorvastatin, 2 simvastatin and 2 cerivastatin, but none to rosuvastatin). 20949552
Saku K, Zhang B, Noda K; The PATROL Trial Investigators. Randomized head-to-head comparison of pitavastatin, atorvastatin, and rosuvastatin for safety and efficacy (quantity and quality of LDL). Circ J 2011; 75: 1493-1505. (Controlled trial comparing 3 potent statins in 302 patients for 16 weeks; ALT elevations above 3 times ULN occurred in 2 on atorvastatin, 2 on rosuvastatin, and 1 on pitavastatin, but none developed clinically apparent liver injury). 21498906
Toth PP, Dayspring TD. Drug safety evaluation of rosuvastatin. Expert Opin Drug Saf 2011; 10: 969-86. (Review of pharmacology, safety and efficacy of rosuvastatin; "compared to other statins, it has no excess signal for liver, skeletal muscle or renal toxicity"). 21999163
Kato JD, Wang CT. Cardiac rehabilitation participant with sickle cell trait and statin-related hepatotoxicity: a case report. J Cardiopulm Rehabil Prev 2012; 32: 182-6. (51 year old man developed marked aminotransferase elevations [ALT 2498 U/L, AST 1452 U/L; Alk P and bilirubin not given] 75 days after starting rosuvastatin, which fell to normal within 3 months of stopping, but rose again 1 month after restarting). 22595892
Björnsson E, Jacobsen EI, Kalaitzakis E. Hepatotoxicity associated with statins: reports of idiosyncratic liver injury post-marketing. J Hepatol 2012; 56: 374-80. (Between 1988 and 2010, the Swedish registry received 217 adverse event reports possibly related to statins, 124 [57%] being liver related, 73 of which could be evaluated: 2 were fatal and one led to liver transplant; 3 had positive rechallenge; 43 [59%] were hepatocellular, 22 [30%] cholestatic and 8 [11%] mixed; 30 were due to atorvastatin, 28 simvastatin, 11 fluvastatin, 2 pravastatin and 2 rosuvastatin, arising after 30-248 days; atorvastatin injury was more likely to be cholestatic and was estimated to occur in 2.9 per 100,000 person years). 21889469
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 6 were attributed to statins: 2 atorvastatin, 2 simvastatin [one with ezetimibe] and 2 cerivastatin, but none to rosuvastatin). 20949552
Vaverkova H, Farnier M, Averna M, Missault L, Viigimaa M, Dong Q, Shah A, et al. Lipid-altering efficacy of ezetimibe/simvastatin 10/20 mg compared to rosuvastatin 10 mg in high-risk patients with and without type 2 diabetes mellitus inadequately controlled despite prior statin monotherapy. Cardiovasc Ther 2012; 30: 61-74. (In a randomized trial in patients with hypercholesterolemia, ALT or AST elevations >3 times ULN occurred in none of 303 patients receiving rosuvastatin versus 0.7% of 312 on the combination of simvastatin and ezetimibe). 20626402
DeGorter MK, Tirona RG, Schwarz UI, Choi YH, Dresser GK, Suskin N, Myers K, et al. Clinical and pharmacogenetic predictors of circulating atorvastatin and rosuvastatin concentrations in routine clinical care. Circ Cardiovasc Genet. 2013;6:400-8. (Measurement of plasma levels of atorvastatin and rosuvastatin in two cohorts [299 and 576 patients] found levels varied 45-fold and were consistently higher in Chinese and Japanese compared to European subjects and that differences could not be completely explained by racial variation in frequencies of SLCO and ABCG2 polymorphisms known to affect peak drug levels). 23876492
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 2 cases due to atorvastatin and 1 to simvastatin, but none to rosuvastatin). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to statins or lipid lowering agents). 24552865
Russo MW, Hoofnagle JH, Gu J, Fontana RJ, Barnhart H, Kleiner DE, Chalasani N, et al. Spectrum of statin hepatotoxicity: Experience of the drug-induced liver injury network. Hepatology 2014; 60: 679-86. (Among 1,188 cases of drug induced liver disease collected in the US between 2004 to 2012, 22 [2%] were attributed to statins, including atorvastatin [8], simvastatin [5], rosuvastatin [4], fluvastatin [2], pravastatin [2], and lovastatin [1]; median age was 60 years and 68% were women; 9 cases were cholestatic and 12 hepatocellular [6 with autoimmune features]; the latency ranged widely, from 1 month to 10 years; only one case was fatal [a man with preexisting cirrhosis presenting with acute-on-chronic liver failure]). 24700436
Bays H, Cohen DE, Chalasani N, Harrison SA. An assessment by the Statin Liver Safety Task Force: 2014 update. J Clin Lipidol 2014; 8 (3 Suppl): S47-57. (Review of the safety of statins including their use in patients with liver disease recommending that liver tests be obtained before therapy, but that routine monitoring is not necessary and that statins can be safety used in patients with nonalcoholic liver disease and are probably safe in other forms of chronic liver disease and after liver transplantation). 24793441
Ooba N, Sato T, Wakana A, Orii T, Kitamura M, Kokan A, Kurata H, et al. A prospective stratified case-cohort study on statins and multiple adverse events in Japan. PLoS One 2014; 9: e96919. (Among 6877 patients started on statins between 2008 and 2010, 139 developed an increase in ALT or AST deemed likely due to the drug with no significant differences among those treated with pra-, ator-, flu-, pita- or rosu-vastatin). 24810427
Macedo AF, Taylor FC, Casas JP, Adler A, Prieto-Merino D, Ebrahim S. Unintended effects of statins from observational studies in the general population: systematic review and meta-analysis. BMC Med 2014; 12: 51. (Systematic review of 90 studies of 48 different "unintended effects" of statins with evidence of an increased risk of myopathy [Odds Ratio: OR=2.6] and raised liver enzymes [OR=1.5]). 24655568
Drugs for lipids. Treat Guidel Med Lett 2014; 12 (137): 1-6. (Concise recommendations on management of hyperlipidemia mentions that 1-2% of patients on high doses of statins develop ALT elevations [above 3 times ULN], but that there is not always cross sensitivity to this side effect and that patients with mild-to-moderate ALT elevations can tolerate statins; no discussion of clinically apparent liver). 24419209
Vishwakarma P, Nehra R, Kumar A. Acute hepatic injury with atorvastatin: an unusual occurrence. Indian J Pharmacol 2014; 46: 343-4. (63 year old man developed jaundice 2 months after starting 20 mg daily of atorvastatin [bilirubin 5.2 mg/dL, ALT 1124 U/L, Alk P 214 U/L], falling to normal within a month of switching to 10 mg daily of rosuvastatin). 24987187
Perdices EV, Medina-Cáliz I, Hernando S, Ortega A, Martín-Ocaña F, Navarro JM, Peláez G, et al. Hepatotoxicity associated with statin use: analysis of the cases included in the Spanish Hepatotoxicity Registry. Rev Esp Enferm Dig 2014; 106: 246-54. (Among 858 cases of drug induced liver injury enrolled in a Spanish Registry between 1994 and 2012, 47 [5.5%] were attributed to statins [16 atorvastatin, 13 simvastatin, 12 fluvastatin, 4 lovastatin, and 2 pravastatin], usually with a hepatocellular pattern of injury, 8.5% with autoimmune features, chronic injury in 19%, and no liver related deaths). 25075655
Chen GL, Hsiao FY, Dong YH, Shen LJ, Wu FL. Statins and the risk of liver injury: a population-based case-control study. Pharmacoepidemiol Drug Saf 2014; 23: 719-25. (Among 2165 Taiwanese patients hospitalized for liver injury between 2002 and 2009, use of statins was not more frequent than among 16,600 hospitalized controls, except for use of high doses of rosuvastatin [adjusted odds ratio of 2.29]). 24829162
Birmingham BK, Bujac SR, Elsby R, Azumaya CT, Zalikowski J, Chen Y, Kim K, et al. Rosuvastatin pharmacokinetics and pharmacogenetics in Caucasian and Asian subjects residing in the United States. Eur J Clin Pharmacol. 2015;71:329-40. (Pharmacokinetic studies using a single oral dose of rosuvastatin [20 mg] showed that East-Asian subjects [Chinese, Filipino, Korean, Vietnamese and Japanese] had greater area under the curve concentrations [64-84% higher] and higher maximum drug concentrations [70-98% higher] than Caucasians, while Asian-Indians demonstrated intermediate levels; higher values were also seen in subjects with polymorphisms in SLCO1B1 and ABCG2 hepatic transporter genes, which may have accounted for some of the differences). 25630984
Birmingham BK, Bujac SR, Elsby R, Azumaya CT, Wei C, Chen Y, Mosqueda-Garcia R, et al. Impact of ABCG2 and SLCO1B1 polymorphisms on pharmacokinetics of rosuvastatin, atorvastatin and simvastatin acid in Caucasian and Asian subjects: a class effect? Eur J Clin Pharmacol. 2015;71:341-55. (Among 96 subjects treated in an open-label, 3-way crossover study of a single oral dose of rosuvastatin [20 mg], atorvastatin [40 mg], or simvastatin [40%], Chinese and Japanese subjects had higher plasma levels than European subjects, and the differences could not be attributed entirely to hepatic transporter polymorphisms {SLCO1B1*1a and ABCG2c.421] known to be associated with higher statin levels). 25673568
Hwang NK, Park JS, Cha KS, Kang JS. Hepatotoxicity associated with a short course of rosuvastatin. Chin Med J (Engl) 2015; 128: 1693-4. (76 year old Korean man with coronary artery disease developed abdominal pain and jaundice 12 days after a percutaneous intervention and starting rosuvastatin [bilirubin 10.3 mg/dL, ALT 612 U/L, Alk P 174 U/L], which resolved rapidly [< 1 week] upon stopping). 26063377
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases [3.4%] were attributed to statins, including 8 to atorvastatin, 8 simvastatin, 7 rosuvastatin, 4 pravastatin, 2 fluvastatin and 2 lovastatin). 25754159
Chang CH, Chang YC, Lee YC, Liu YC, Chuang LM, Lin JW. Severe hepatic injury associated with different statins in patients with chronic liver disease: a nationwide population-based cohort study. J Gastroenterol Hepatol 2015; 30: 155-62. (Among 37,929 Taiwanese persons with chronic liver disease started on statin therapy for hyperlipidemia between 2005 and 2009, there were 912 incident cases of hospitalization for liver injury, rates being similar for the 6 different statins used [1.94-2.95 per 100,000 person-days], but higher in those on high doses of atorvastatin [40 or 80 mg daily]). 25041076
Kim HS, Lee SH, Kim H, Lee SH, Cho JH, Lee H, Yim HW, et al. Statin-related aminotransferase elevation according to baseline aminotransferases level in real practice in Korea. J Clin Pharm Ther 2016; 41: 266-72. (Among 21,233 Korean patients starting statin therapy between 2009 and 2013, abnormal ALT or AST values above 3 times ULN were more frequent among those with mild baseline elevations). 27015878
Yusuf S, Bosch J, Dagenais G, Zhu J, Xavier D, Liu L, Pais P, et al.; HOPE-3 Investigators. cholesterol lowering in intermediate-risk persons without cardiovascular disease. N Engl J Med. 2016;374:2021-31. (Among 12,705 adults with intermediate cardiovascular risk treated with rosuvastatin [10 mg] or placebo daily for a median period of 5.6 years, LDL-cholesterol levels were 26.5% lower and cardiovascular endpoints 24% lower with statin therapy, while muscle pain or weakness was more frequent with statins [5.8% vs 4.7%], myopathy and liver test abnormalities were rare [<1% in both groups]). 27040132
Wang LY, Huang YS, Perng CL, Huang B, Lin HC. Statin-induced liver injury in an area endemic for hepatitis B virus infection: risk factors and outcome analysis. Br J Clin Pharmacol 2016; 82: 823-30. (Analysis of the Taipei Veterans Hospital database from 2008 to 2012 identified 108 patients with statin associated liver injury [including 28 rosu-, 20 flu-, 17 sim-, 11 pra-, 8 lo-, and 8 pita-vastatin] most of which 75 [69%] were mild and only one fatal [80 year old on rosu-], and there were no differences in disease features or peak enzyme or bilirubin levels between HBsAg positive vs negative subjects [n=16 vs 92]). 27197051
Wu HF, Hristeva N, Chang J, Liang X, Li R, Frassetto L, Benet LZ. Rosuvastatin pharmacokinetics in Asian and White subjects wild type for both OATP1B1 and BCRP under control and inhibited conditions. J Pharm Sci. 2017;106:2751-2757. (Pharmacokinetic studies of rosuvastatin in Asian and White subjects found differences in peak plasma levels that could not be attributed to differences in hepatic transporter alleges [SLCO1B1*1a or ABCG2c.421]). 28385543
Björnsson ES. Hepatotoxicity of statins and other lipid-lowering agents. Liver Int 2017; 37: 173-8. (Review of the hepatotoxicity of statins mentions that atorvastatin has been the most frequently implicated statin [accounting for 30-40% of cases] in drug induced liver injury estimated to arise in 1 in 17,000 users, cholestatic in 56% and with autoimmune features in 10% and rarely fatal). 27860156
Sánchez M, Castiella A, Zapata E, Zubiaurre L, Pérez-Yeboles J, Mendibil L, Iribarren A. Autoimmune hepatitis (immune-mediated liver injury) induced by rosuvastatin. Gastroenterol Hepatol. 2018;41:311-313. (47 year old man was found to have abnormal liver tests 10 months after switching from atorvastatin to rosuvastatin [bilirubin 0.7 mg/dL, ALT 201 U/L, Alk P 77 U/L, ANA 1:160], with worsening for several weeks after stopping but ultimate spontaneous complete resolution with normal liver tests and ANA negativity). 28655408
Hong SJ, Jeong HS, Ahn JC, Cha DH, Won KH, Kim W, Cho SK, et al. A phase III, multicenter, randomized, double-blind, active comparator clinical trial to compare the efficacy and safety of combination therapy with ezetimibe and rosuvastatin versus rosuvastatin monotherapy in patients with hypercholesterolemia: I-ROSETTE (Ildong Rosuvastatin & Ezetimibe for Hypercholesterolemia) randomized controlled trial. Clin Ther. 2018;40:226-241.e4. (Among 396 Korean patients with hypercholesterolemia treated with rosuvastatin [5, 10 or 20 mg daily] with or without ezetimibe [10 mg daily] for 8 weeks, the percent decrease in LDL-cholesterol was higher at each dose of rosuvastatin combined with ezetimibe [overall -57% vs -44%] and the proportion of patients achieving a targeted goal of LDL-cholesterol was also higher [92% vs 80%], while there were similar rates of total adverse events [11.2% vs 11.3%], serious adverse events [0.5% vs 0.5%] as well as ALT elevations above 3 times the ULN [0.6% vs 0]). 29402522
Tirona RG, Kassam Z, Strapp R, Ramu M, Zhu C, Liu M, Schwarz UI, et al. Apixaban and rosuvastatin pharmacokinetics in nonalcoholic fatty liver disease. Drug Metab Dispos. 2018;46:485-492. (Analysis of pharmacokinetics of rosuvastatin in patients with nonalcoholic fatty liver were not different from those in healthy volunteers but did vary by body weight). 29472495
Teschke R. Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. 2018;14:1169-1187. (A compilation of national and international databases on drug induced liver injury identified the ten top-ranking causes which included two statins, atorvastatin [ranking 3^rd^], and simvastatin [ranking 6^th^]). 30354694
Moore N, Duret S, Grolleau A, Lassalle R, Barbet V, Duong M, Thurin N, et al. Previous drug exposure in patients hospitalised for acute liver injury: a case-population study in the French National Healthcare Data System. Drug Saf. 2019;42:559-572. (Analysis of a French nationwide health database for medication use and hospitalizations for unexplained acute liver injury identified 4807 cases, 76% of which had been exposed to at least one medication in the previous 7-60 days, 263 cases [5.5%] had taken atorvastatin, but the exposed/case ratio was 15,742; 182 cases [3.8%} had taken rosuvastatin, the exposed/case ratio being 20,359; while only 10 cases had taken pyrazinamide but with an exposed/case ratio of 770). 30361989
Yebyo HG, Aschmann HE, Kaufmann M, Puhan MA. Comparative effectiveness and safety of statins as a class and of specific statins for primary prevention of cardiovascular disease: A systematic review, meta-analysis, and network meta-analysis of randomized trials with 94,283 participants. Am Heart J. 2019;210:18-28. (Metaanalyses of 40 trials of statins that enrolled 94,283 patients followed for a median of 1 year for efficacy and safety reported that statins as a class increased the risk of hepatic dysfunction by 6% with fluvastatin having the highest relative risk). 30716508
Lipid-lowering drugs. Med Lett Drugs Ther. 2019;61(1565):17-24. (Concise review of the mechanism of action, relative efficacy, safety and costs of lipid lowering drugs including statins, ezetimibe, PCSK9 inhibitors, bile acid sequestrants, fibric acid derivatives, niacin and fish oil, mentions that statin therapy is associated with ALT elevations above 3 times ULN in 1-3% of patients but “whether statins actually cause liver damage is unclear”). 30845106
Hung TH, Tsai CC, Lee HF. Statin use in cirrhotic patients with infectious diseases: A population-based study. PLoS One. 2019;14:e0215839. (Analysis of the Taiwan National Health Insurance Database identified 816 patients with cirrhosis receiving statins [including rosuvastatin] who were hospitalized for bacterial infections and similar number of cirrhotic controls not on statins, found a lower 30-day mortality with statins: 5.3% vs 9.8%). 31017946
Shah J, Lingiah V, Pyrsopoulos N, Galan M. Acute liver injury in a patient treated with rosuvastatin: a rare adverse effect. Gastroenterology Res. 2019;12:263-266. (47 year old Peruvian man developed jaundice 6 weeks after starting rosuvastatin [5 mg daily] [bilirubin 3.5 rising to 17.2 mg/dL, ALT 2260 U/L, Alk P 277 U/L, INR 1.1, ANA negative], liver biopsy with changes suggestive of autoimmune hepatitis, treated with methylprednisolone with gradual resolution of injury). 31636777
Courlet P, Livio F, Alves Saldanha S, Scherrer A, Battegay M, Cavassini M, Stoeckle M, et al.; Swiss HIV Cohort Study. Real-life management of drug-drug interactions between antiretrovirals and statins. J Antimicrob Chemother. 2020;75:1972-1980. (Assessment of lipid levels in persons living with HIV who were taking rosuvastatin found that one-third had suboptimal lipid control despite high doses, perhaps due to drug-drug interactions including inhibition of OATP1b1 causing poor hepatic uptake of statin). 32240298
Kawasaki E, Fukuyama T, Kuriyama E, Uchida A, Sagara Y, Tamai H, Nakano Y, et al. Statin-induced autoimmune hepatitis in patients with type 1 diabetes: A report of two cases and literature review. J Diabetes Investig. 2020;11:1673-1676. (Two men, ages 46 and 54, with type 1 diabetes developed hepatitis 6 and 8 months after starting atorvastatin and rosuvastatin [bilirubin 5.1 and unknown mg/dL, ALT 1632 and 709 U/L, Alk P not given and 2055 U/L, ANA 1:80 and negative, IgG 1495 and 1857 mg/dL], both with autoimmune hepatitis-like features on liver biopsy and both with response to corticosteroid therapy). 32277861
Balasubramanian R, Maideen NMP. HMG-CoA reductase inhibitors (statins) and their drug interactions involving CYP enzymes, P-glycoprotein and OATP transporters-an overview. Curr Drug Metab. 2021;22:328-341. (Systematic review of literature on drug-drug interactions with statins and their clinical significance mentions that toxicity can be enhanced by inhibitors of CYP3A4 [atorva-, simva- and lova-statin] as well as by inhibitors of P glycoprotein and OATP1B1 [most statins including rosuvastatin], with specific recommendations for the most common inhibitors). 33459228
Sung S, Al-Karaghouli M, Kalainy S, Cabrera Garcia L, Abraldes JG. A systematic review on pharmacokinetics, cardiovascular outcomes and safety profiles of statins in cirrhosis. BMC Gastroenterol. 2021;21:120. (Systematic review of literature suggests that rosuvastatin and pitavastatin pharmacokinetics are unchanged in patients with Child Class A cirrhosis as opposed to atorvastatin and pravastatin, although unlike rosuvastatin, simvastatin, atorvastatin and pravastatin have been assessed in clinical trials in cirrhotic patients). 33726685
Onfiani G, Nascimbeni F, Carubbi F. A case of statin-induced liver injury with positive rechallenge with a second statin. Is there a class effect? J Basic Clin Physiol Pharmacol. 2021; 32:1151-155. (58 year old woman on long term simvastatin therapy developed ALT elevations 2 months after dose increase from 10 mg to 20 mg daily [ALT 314 U/L] without symptoms, Alk P or bilirubin elevations, which was normal 2 months after stopping but was elevated again without symptoms or jaundice 2 months after starting rosuvastatin in a dose of 5 mg daily [ALT 542 U/L], slowing falling to normal 5 months after stopping statins a second time). 33882199
Cai T, Abel L, Langford O, Monaghan G, Aronson JK, Stevens RJ, Lay-Flurrie S, et al. Associations between statins and adverse events in primary prevention of cardiovascular disease: systematic review with pairwise, network, and dose-response meta-analyses. BMJ. 2021;374:n1537. (Systematic review of placebo controlled trials of statins for cardiovascular disease prevention identified 62 publications with 120,456 patients and found an increased risk of muscle symptoms, liver test abnormalities, renal insufficiency and eye conditions for all 7 statins, but not muscle disorders or diabetes, rosuvastatin having relatively high risk for muscle symptoms and renal abnormalities and also was also associated with eye conditions and diabetes, while atorvastatin and lovastatin had highest risk for liver abnormalities). 34261627
Vijayakanthi N, Felner EI, Romero R, Daley TC. Rhabdomyolysis due to rosuvastatin in a patient with ROHHAD syndrome. J Clin Lipidol. 2021; 15:789-792. (13 year old with obesity, NASH and panhypopituitarism developed rhabdomyolysis two weeks after switching from lovastatin [40 mg/daily taken for 8 years] to rosuvastatin [40 mg daily] [bilirubin not given, ALT 298 U/L, AST 558 U/L, Alk P not given, CPK 53,000 U/L, creatinine 2.2 mg/dL, drug levels not given], with rapid improvement on stopping). 34600840
Castermans A, Hias J, Van der Linden L, Spriet I, Tournoy J. [Case of hepatotoxicity of atorvastatin: the search for a possible etiology]. Tijdschr Gerontol Geriatr. 2022;53. Dutch. (75 year old woman with a history of liver test abnormalities while taking 20 mg of atorvastatin daily [bilirubin 0.6 mg/dL, ALT 460 U/L, Alk P 341 U/L] re-developed abnormalities on restarting 80 mg of atorvastatin 7 years later [bilirubin 0.4 mg/dL, ALT 121 U/L, Alk P 312 U/L], later tolerating rosuvastatin without liver test abnormalities).
Verma SK, Huang J, Hutchinson HG, Estevez I, Kuang K, Reynolds SL, Schneeweiss S. Statin use and severe acute liver Injury among patients with elevated alanine aminotransferase. Clin Epidemiol. 2022;14:1535-1545. (Among 149,410 adults identified in two health insurance databases who initiated statin therapy, 32 developed serious liver injury [20 per 100,000 person years], a rate similar to that of a matched cohort of 517,200 who did not start statins [25 per 100,000]; furthermore, the presence of preexisting ALT elevations was not associated with development of serious liver injury [16 vs 19 per 100,000]). 36540900
Malani SK, Chigullapalli S, Sujanyal S, Sharma V. Rosuvastatin-Induced myopathy: a case series. Cureus. 2024;16:e66180. (Description of 3 patients who developed severe myopathy months after starting rosuvastatin [40 mg daily], with muscle weakness with variable elevations in serum ALT [56, 514, 724 U/L], but greater increases in AST [35, 1290, 1074 U/L] and CPK [2030, 46,868, 53,240 U/L], no increase in Alk P, and no or minimal increase in bilirubin [0.4, 1.5, 0.4 mg/dL], and recovery within 2 months after stopping). 39233949
Su FY, Li WH, Zhao XD, Han Q, Xu X, Geng T. Risk factors analysis of severe liver injury induced by statins. Horm Metab Res. 2024;56:419-423. (Among 1,211 cases of statin induced liver injury reported to a Chinese database between 2013 and 2021, 157 were considered “severe” [ALT ≥400 U/L or bilirubin ≥2.0 mg/dL], and risk factors for severity included older age, combination with other drugs or herbs, and atorvastatin). 37956980
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records from between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications, at a rate of 1 per10,100 patients exposed to atorvastatin and 1 per 14,285 exposed to rosuvastatin). 38913369
Lammert C, Teal E, Ghabril M, Chalasani N. Incidence of possible drug-induced liver injury due to commonly implicated agents in the United States. Clin Gastroenterol Hepatol. 2024: Oct 22. [online ahead of print]. (Analysis of a health database of 16 Indiana University Health hospitals, identified 54 cases of drug induced liver injury 918 per 100,000 persons exposed, the incidence being 1:23,510 for those treated with atorvastatin, no data available on rosuvastatin).
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. (Analysis of 1284 cases of drug induced liver injury enrolled in a US prospective study identified 7 cases of rosuvastatin, which was consistent with an incidence of 1 per 16,000 persons treated with rosuvastatin compared to 1 per 10,000 with atorvastatin, and 1 per 52,000 with simvastatin). 39317916
Wang B, Huang S, Li S, Deng Y, Li Z, Wang Y, Shi X, et al. Hepatotoxicity of statins: a real-world study based on the US Food and Drug Administration Adverse Event Reporting System database. Front Pharmacol. 2025;15:1502791. (Analysis of the FDA Adverse Event Reporting System for reports of liver injury attributed to statins between 2004 and 2024 identified 14,511 instances, atorvastatin being the most frequently listed [n=7,903] followed by simvastatin [3,074], rosuvastatin [2,512], pravastatin [458], fluvastatin [262], pitavastatin [178], and lovastatin [124], fatal cases accounting for 2.5% to 5.6%). 39840096

## OTHER REFERENCE LINKS

1. Recent References on Rosuvastatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=rosuvastatin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Rosuvastatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=rosuvastatin)